# Salicylates

## OVERVIEW

The following links are to individual drug records.

1 Aspirin
2 Diflunisal
3 Salsalate
4 Trisalicylate

## OTHER REFERENCE LINKS

1 Recent References on Salicylates: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=salicylates/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Salicylates: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=salicylates)